# Clomiphene

## OVERVIEW

### Introduction

Clomiphene is an oral agent used to treat infertility in women desiring pregnancy. Clomiphene has been linked to a low rate of transient serum aminotransferase elevations during therapy and to rare instances of clinically apparent liver injury, which can be severe and even fatal.

### Background

Clomiphene (kloe' mi feen) is an orally available, nonsteroidal antiestrogen that stimulates ovulation and is used largely as therapy of infertility in women. Clomiphene interacts with estrogen receptors in many tissues, including the hypothalamus, pituitary, ovary, endometrium, vagina and cervix. The inhibition of estrogen effects by clomiphene leads to release of pituitary follicular stimulating hormone (FSH), which initiates growth and maturation of the ovarian follicle, follicular rupture and ovulation. In clinical trials, clomiphene resulted in pregnancies in approximately 30% of patients. Clomiphene was approved for use in the United States in 1967, and current indications are for treatment of ovulatory dysfunction in women desiring pregnancy. Clomiphene is available in tablets of 50 mg generically and under the brand name Clomid. The recommended dose is 50 mg daily for 5 days. Common side effects include headache, nausea, anorexia, diarrhea, rash and renal dysfunction. Uncommon, but potentially severe adverse events include hypersensitivity reactions, visual disturbance, abdominal pain, multiple pregnancies, and ovarian hyperstimulation syndrome.

### Hepatotoxicity

There is little information on serum aminotransferase levels during clomiphene therapy which is typically given in low doses for a short time only. There have been a few reports of mild serum enzyme elevations in patients taking clomiphene, but no convincing instances of idiosyncratic, clinically apparent liver injury with its use.

Drugs used to treat infertility in women typically act by stimulation of the ovarian follicles which can lead to the ovarian hyperstimulation syndrome (OHSS), which can occasionally be accompanied by serum enzyme elevations and even jaundice. This syndrome typically arises within 4 to 14 days of ovarian stimulation with gonadotropins or clomiphene and is characterized by the onset of abdominal pain and distension with ascites and enlarged ovaries and ovarian cysts. There can be marked fluid shifts with hemoconcentration and rapid onset of severe ascites and pleural effusions. Liver tests are elevated in 25% to 40% of patients with OHSS, typically with mild-to-moderate increases in ALT and AST values, but minimal or no elevations in serum bilirubin and alkaline phosphatase levels. The liver test abnormalities resolve with resolution of the OHSS, usually within 2 to 3 weeks of onset. In severe instances, OHSS can be fatal, but death is usually due to dehydration, shock and septicemia rather than hepatic failure. In typical cases with abnormal liver enzymes, liver histology reveals nonspecific changes of sinusoidal dilatation, mild fat accumulation and focal inflammatory infiltrates with macrophages and lymphocytes. OHSS is less common with clomiphene than with human chorionic gonadotropin (hCG) induction of ovulation.

Likelihood score: C (probable cause of clinically apparent liver injury as a part of the ovarian hyperstimulation syndrome).

### Mechanism of Injury

The mechanism of injury accounting for serum enzyme elevations during clomiphene therapy is not known. Clomiphene is metabolized in the liver and has a prolonged half-life. The liver test abnormalities found during OHSS may be due to fluid shifts, hypovolemia and ischemia.

### Outcome and Management

Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) should lead to dose reduction or temporary cessation. Clomiphene has not been implicated in cases of acute liver failure, chronic hepatitis or vanishing bile duct syndrome. There does not appear to be cross reactivity in risk for hepatic injury between clomiphene and other drugs used to treat infertility.

Drug Class: Infertility Agents

Other Drugs in the Class: Letrozole, Tamoxifen

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Clomiphene – Generic, Clomid®

DRUG CLASS

Infertility Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Clomiphene)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Clomiphene | 911-45-5 | C26-H28-Cl-N-O | Clomiphene Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 17 October 2017

Zimmerman HJ. Hormonal derivatives and related drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp 555-88. (Review of hepatotoxicity published in 1999; clomiphene is mentioned as having been linked unconvincingly to one case of hepatoblastoma [in a child born to a woman who received clomiphene] and one adenoma).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Textbook on hepatotoxicity; clomiphene not discussed).
Schimmer BP, Parker KL. Contraception and pharmacotherapy of obstetrical and gynecological disorders. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1833-52. (Textbook of pharmacology and therapeutics).
Bjork JT, Varma RR, Borkowf HI. Clomiphene citrate therapy in a patient with Laennec's cirrhosis. Gastroenterology 1977; 72: 1308-11. (37 year old man with alcoholic cirrhosis who was abstinent from alcohol was treated with clomiphene with increase in FSH, LH and testosterone levels and improvement in impotence but not gynecomastia; mildly abnormal liver tests did not change during treatment). 858474
Lunenfeld B, Blankstein J, Kotev-Emeth S, Kokia E, Geier A. Drugs used in ovulation induction. Safety of patient and offspring. Hum Reprod 1986; 1: 435-9. (Review of safety of clomiphene and human chorionic gonadotropin used as therapy of infertility in women to induce ovulation; no mention of ALT elevations or hepatotoxicity). 3106402
Younis JS, Zeevi D, Rabinowitz R, Laufer N, Schenker JG. Transient liver function tests abnormalities in ovarian hyperstimulation syndrome. Fertil Steril 1988; 50: 176-8. (2 women, ages 24 and 28 years, developed abdominal pain and distension, nausea and dyspnea 7 and 16 days after aspiration of oocytes and therapy with human chorionic gonadotropin [bilirubin 0.7 and 0.8 mg/dL, ALT 103 and 124 U/L, Alk P 94 and 115 U/L, albumin 2.0 and 3.3 g/dL], resolving with resolution of the ascites and ovarian enlargement within 3-4 weeks). 3384112
Sueldo CE, Price HM, Bachenberg K, Steinleitner A, Gitlin N, Swanson J. Liver dysfunction in ovarian hyperstimulation syndrome. A case report. J Reprod Med 1988; 33: 387-90. (29 year old woman with infertility developed ascites and OHSS within a week of stopping a course of human menopausal gonadotropin [bilirubin 2.8 mg/dL, ALT 207 rising to 880 U/L, Alk P 111 U/L], liver biopsy was largely normal except for intramitochondrial paracrystaliine inclusions). 3130483
Ryley NG, Forman R, Barlow D, Fleming KA, Trowell JM. Liver abnormality in ovarian hyperstimulation syndrome. Hum Reprod 1990; 5: 938-43. (32 year old woman with infertility treated with human gonadotropin and embryo transfer developed nausea, abdominal distension, marked ascites and hypovolemic shock [peak bilirubin 1.5 mg/dL, AST 255 U/L, Alk P 1173 U/L], biopsy showing fatty change and focal infiltrates, resolving after "evacuation of products"). 1982004
Balasch J, Carmona F, Llach J, Arroyo V, Jové I, Vanrell JA. Acute prerenal failure and liver dysfunction in a patient with severe ovarian hyperstimulation syndrome. Hum Reprod 1990; 5: 348-51. (27 year old woman with infertility developed abdominal pain, distension, ascites, nausea and dyspnea 5 days after follicular aspiration and treatment with hCG [bilirubin rising to 4.4 m/dL, ALT 49 U/L, Alk P 627 U/L], resolving within 2-3 weeks). 2112558
Marsepoil T, Cordesse A, Varguy P, Dauptain G, Levesque P. [Hepatic involvement in the course of ovarian hyperstimulation syndrome]. Rev Fr Gynecol Obstet 1992; 87: 148-9. French. (22 year old woman with infertility developed OHSS shortly after receiving clomiphene and hCG with ascites and pleural effusions [ALT rising to 40 times ULN, bilirubin and Alk P normal], biopsy showing mild portal inflammation and sinusoidal dilatation without hepatocyte necrosis, resolving within 2 months). 1579800
Senturk H, Erdinç, Tasyurekli M, Mert A, Arvas M, Sen C. Case report: liver function abnormalities in a severe case of hyperreactio luteinalis. J Gastroenterol Hepatol 1996; 11: 617-20. (A 12 week pregnant 19 year old developed multicystic ovarian masses and ascites with rises in liver tests [peak bilirubin 2.0 mg/dL, ALT 214 U/L], resolving within 2-3 weeks). 8840234
Wakim AN, Fox SD. Elevated liver function tests in a case of moderate ovarian hyperstimulation syndrome. Hum Reprod 1996; 11: 588-9. (28 year old woman with infertility was treated with clomiphene and hCG for ovarian stimulation developed abdominal pain and ascites [ALT 183 U/L, bilirubin and Alk P normal], resolving within 2 weeks of onset at time of resolution of ascites). 8671272
Nawroth F, Heinrich J, Bruns U, Wood WG. Severe ovarian hyperstimulation syndrome (OHSS) and icterus. Hum Reprod 1996; 11: 2441-2. (33 year old woman with infertility treated with clomiphene and HCG developed nausea and distended abdomen with ascites and enlarged ovaries [bilirubin rising to 5.2 mg/dL, ALT 184 U/L, Alk P normal], resolving within 2-3 weeks). 8981129
Rizk B, Aboulghar M, Smitz J, Ron-El R. The role of vascular endothelial growth factor and interleukins in the pathogenesis of severe ovarian hyperstimulation syndrome. Hum Reprod Update 1997; 3: 255-66. (Review of OHSS including clinical presentation with massive cystic enlargement of ovaries and fluid shift with ascites, pleural effusions and hypovolemia caused by cytokines and growth factors [VEGF] induced by ovarian stimulation by gonadotropin therapy). 9322101
Shimono J, Tsuji H, Azuma K, Hashiguchi M, Fujishima M. A rare case of hepatic injury associated with ovarian hyperstimulation syndrome. Am J Gastroenterol 1998; 93 (1): 123-4. (26 year old woman treated with menopausal gonadotropin and clomiphene to prevent spontaneous abortion developed massive ascites and multiple ovarian cysts [bilirubin 1.3 mg/dL, ALT 194 U/L], with subsequent resolution, but spontaneous abortion a few weeks later). 9448194
Midgley DY, Khalaf Y, Braude PR, Nelson-Piercy C. Recurrent cholestasis following ovarian hyperstimulation syndrome: case report. Hum Reprod 1999; 14: 2249-51. (34 year old woman with infertility developed OHSS 4 weeks after successful embryo transfer with ascites and enlarged ovaries [ALT 65 U/L] and then at 9 weeks developed pruritus and cholestasis of pregnancy [ALT 215 U/L, elevated bile acids], and then developed preeclampsia and cholestasis again [ALT ~350 U/L], resolving with delivery of normal twins). 10469689
Fábregues F, Balasch J, Ginès P, Manau D, Jiménez W, Arroyo V, Creus M, et al. Ascites and liver test abnormalities during severe ovarian hyperstimulation syndrome. Am J Gastroenterol 1999; 94: 994-9. (Among 50 women with OHSS admitted over a 7 year period to a single referral center, all developed ascites between 4 and 11 days after ovulation induction with gonadotropins, 15 had abnormal liver tests [bilirubin normal, ALT 51-277 U/L, Alk P 83-411 U/L], resolving within 1-3 weeks along with ascites). 10201472
Chen CD, Wu MY, Chen HF, Chen SU, Ho HN, Yang YS. Relationships of serum pro-inflammatory cytokines and vascular endothelial growth factor with liver dysfunction in severe ovarian hyperstimulation syndrome. Hum Reprod 2000; 15: 66-71. (Among 29 women with OHSS after in vitro fertilization, 15 had abnormal liver tests [bilirubin 1.2-2.6 mg/dL, ALT 35-144 U/L, Alk P 64-238 U/L]). 10611190
Elter K, Scoccia B, Nelson LR. Hepatic dysfunction associated with moderate ovarian hyperstimulation syndrome. A case report. J Reprod Med 2001; 46: 765-8. (33 year old woman with infertility developed abdominal distension, ascites and OHSS 11 days after embryo transfer, with daily injections of leuprolide and several injections of FSH, hCG and progesterone [ALT 265 U/L, bilirubin and Alk P normal], resolving in 1-2 weeks). 11547654
Davis AJ, Pandher GK, Masson GM, Sheron N. A severe case of ovarian hyperstimulation syndrome with liver dysfunction and malnutrition. Eur J Gastroenterol Hepatol 2002; 14: 779-82. (28 year old woman with infertility developed abdominal pain and distension 1 day after embryo transfer [bilirubin 0.6 mg/dL, ALT 462 U/L, Alk P 706 U/L, prothrombin time 19 sec], resolving over the ensuing 3 weeks). 12169989
Delvigne A, Rozenberg S. Review of clinical course and treatment of ovarian hyperstimulation syndrome (OHSS). Hum Reprod Update 2003; 9: 77-96. (Review of OHSS mentions that liver abnormalities occur in 26-40% of cases, typically with elevations in ALT, but normal bilirubin and Alk P values, resolving in all cases with resolution of the syndrome). 12638783
Obrzut B, Kuczyński W, Grygoruk C, Putowski L, Kluz S, Skret A. Liver dysfunction in severe ovarian hyperstimulation syndrome. Gynecol Endocrinol 2005; 21: 45-9. (32 year old woman with infertility developed severe OHSS with marked ascites, dyspnea and hypovolemia after therapy with clomiphene and human chorionic gonadotropin [bilirubin 5 mg/dL, ALT 3372 U/L, Alk P 310 U/L], with full recovery over the ensuing month). 16048801
Binder H, Dittrich R, Einhaus F, Krieg J, Müller A, Strauss R, Beckmann MW, Cupisti S. Update on ovarian hyperstimulation syndrome: Part 1--Incidence and pathogenesis. Int J Fertil Womens Med 2007; 52: 11-26. (Review of OHSS, which arises in 0.2-1% of stimulation cycles in assisted reproduction and may be mediated by VEGF levels of which correlate with hCG levels; liver enzyme elevations, predominantly ALT and AST, arise in 25-40% of cases possibly due to the increased capillary permeability of OHSS). 17987884
Mitchell C, Gottlieb L. Transaminitis after treatment with clomiphene citrate: a case report. J Reprod Med 2007; 52 437-8. (30 year old woman developed severe abdominal pain a few days after each of two courses of clomiphene [bilirubin 1.3 mg/dL, ALT 338 U/L, Alk P 87 U/L], ultrasound showing fatty liver without ascites, resolving within 2 months of onset). 17583249
Drugs for ovulation induction. Med Lett Drugs Ther 2011; 53 (1376): 86-8. (Concise review of the efficacy and safety of drugs used for ovarian induction mentions that common side effects of clomiphene are hot flushes, gastrointestinal upset, headache, breast discomfort and uterine bleeding and that clomiphene, particularly in combination with FSH or LH, can cause OHSS which can be severe and even fatal; no mention of ALT elevations or hepatotoxicity). 22033212
Figueiredo JB, Nastri CO, Vieira AD, Martins WP. Clomiphene combined with gonadotropins and GnRH antagonist versus conventional controlled ovarian hyperstimulation without clomiphene in women undergoing assisted reproductive techniques: systematic review and meta-analysis. Arch Gynecol Obstet 2013; 287: 779-90. (Review of 7 studies comparing the safety of regimens to induce ovulation with or without clomiphene mentions that OHSS is less common in regimens that include clomiphene [0.5% vs 4%]). 23250342
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to clomiphene or other agents used for infertility). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Clomiphene: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Clomiphene+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Clomiphene: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Clomiphene)